# Daprodustat

## OVERVIEW

### Introduction

Daprodustat is an orally available small molecule inhibitor of hypoxia-inducible factor prolyl hydroxylase that is used to treat the anemia of chronic renal disease in patients on dialysis. Daprodustat is associated with a low rate of transient and usually mild elevations in serum aminotransferase levels during therapy but has yet to be linked to cases of clinically apparent acute liver injury.

### Background

Daprodustat (dap” roe doo’ stat) is an orally available, specific inhibitor of hypoxia-inducible factor prolyl hydroxylase that is used to treat patients with anemia and chronic renal disease on dialysis. Hypoxia-inducible factor 1α and 1β are subunits of a heterodimeric small transcription factor HIF1, which are constitutively produced at low levels, and in response to hypoxia they are free to dimerize and induce the expression of genes that cause increase in erythropoietin and subsequent increase in hemoglobin. With normal oxygen tension, propyl hydrolase inactivates HIF1α and causes its degradation preventing it from dimerizing with HIF 1β, and as a result erythropoiesis is not increased. By inhibiting prolyl hydroxylase, daprodustat mimics hypoxic conditions and causes an increase in erythropoietin and increased erythropoiesis. In several animal models of chronic renal disease and anemia, daprodustat was found to increase erythropoietin and hemoglobin levels. In an open label trial in adult patients with chronic renal disease and anemia who were on dialysis, daily oral doses of daprodustat resulted in increases in hemoglobin levels similar to those induced by injections of recombinant forms of erythropoietin. A similar result was shown in renal disease patients with anemia who were not on dialysis, but in this group, there was a slight but significant increase in cancers, increased tumor progression, and cancer recurrences with daprodustat in comparison to recombinant erythropoietin. Based upon these results, daprodustat was given accelerated approval as therapy of adults with renal disease and anemia but only those who were on dialysis. Daprodustat is available in tablets of 1, 2, 4, 6 and 8 mg under the brand name Jesduvroq. The recommended starting dose is based upon hemoglobin levels, liver function, and concomitant medications. The dose is then adjusted based upon hemoglobin levels and tolerance (maximum 24 mg once daily). Adverse events are frequent in patients with renal failure on hemodialysis, but adverse events that appear more frequently on daprodustat therapy include hypertension, gastrointestinal erosions, hypersensitivity reactions, and rash. Uncommon and potentially severe adverse events include retinal hemorrhage, thromboembolic events (such as vascular access thrombosis and cerebral infarction), increase risk of death from myocardial infarction or stoke, worsening of heart failure, and possibly increased risk of malignancy. These uncommon but severe adverse events may also be increased with chronic therapy with erythropoietin.

### Hepatotoxicity

In the open label prelicensure clinical trials of daprodustat in patients with renal disease, serum aminotransferase elevations 3 times the upper limit of normal (ULN) or above occurred in 1.7% of subjects, and elevations of 5 times ULN or above in 1.1%. However, similar rates of ALT and AST elevations occurred in placebo and erythropoietin treated participants. The elevations were typically mild and transient and there were no instances of serum aminotransferase elevations with jaundice that were attributed to daprodustat therapy. Since approval and more widescale availability of daprodustat, there have been no published reports of clinically apparent liver injury associated with its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of mild serum enzyme elevations during daprodustat therapy is not known but is possibly due to the underlying chronic renal disease, its management, and complications. Daprodustat is metabolized in the liver by the cytochrome P450 system, predominantly CYP 2D8, and serum levels can be affected by agents that inhibit (such as gemfibrozil and clopidogrel) or induce (such as rifampin) this microsomal drug metabolizing enzyme.

### Outcome and Management

Monitoring of serum aminotransferase levels and routine liver tests is recommended for patients starting daprodustat, and liver chemistries should be repeated during therapy if symptoms or signs of liver injury arise. De novo elevations in serum aminotransferase levels above 5 times the upper limit of normal should lead to at least temporary cessation of drug and search for other causes. If serum enzyme elevations do not resolve or if symptoms of liver injury or jaundice arise, daprodustat should be discontinued.

Drug Class: Hematologic Agents, Hematologic Growth Factors, Erythropoiesis Stimulating Agents

Other Erythropoiesis Stimulating Agents: Epoetin, Darbepoetin, Peginesatide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Daprodustat – Jesduvroq®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Daprodustat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Daprodustat | 960539-70-2 | C19-H27-N3-O6

## ANNOTATED BIBLIOGRAPHY

References updated: 15 July 2024

Abbreviations used: ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of daprodustat or erythropoietin).
FDA. Integrated Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216951Orig1s000IntegratedR.pdf (FDA drug approvals website that has product labels [package inserts], letters of approval, and full FDA scientific review of the new drug application of daprodustat for safety and efficacy, mentions that de novo ALT and AST elevations arose in less than 2% of patients on daprodustat, and similar rates were found among subjects receiving placebo or erythropoietin, and specific review found no evidence of drug induced liver injury, but still recommended that patients have routine liver tests monitored before starting treatment and again during therapy if signs or symptoms of liver disease arise).
Meadowcroft AM, Cizman B, Holdstock L, Biswas N, Johnson BM, Jones D, Nossuli AK, et al. Daprodustat for anemia: a 24-week, open- label, randomized controlled trial in participants on hemodialysis. Clin Kidney J. 2019;12:139-148. (Among 216 patients with anemia and chronic renal disease on dialysis treated with one of five doses of daprodustat [4,6,8,10,12 mg] vs placebo daily for 4 weeks after withdrawal of erythropoietin therapy, there were dose related changes in hemoglobin levels [from -0.29 to +0.69 vs -0.11 g/dL in controls] but rates were similar for total adverse events [73% vs 79%] and serious adverse events [18% vs 26%], symptoms more frequent with daprodustat were diarrhea, nausea, and hypertension; and “no adverse trends were noted for clinical laboratory values”). 30746141
Dhillon S. Daprodustat: first approval. Drugs. 2020;80:1491-1497. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of daprodustat shortly after its approval as therapy of anemia in chronic renal disease in Japan, mentions that adverse events included retinal hemorrhage, hypersensitivity reactions, and hypertension; no mention of ALT elevations or hepatotoxicity). 32880805
Singh AK, Carroll K, McMurray JJV, Solomon S, Jha V, Johansen KL, Lopes RD, et al.; ASCEND-ND Study Group. Daprodustat for the treatment of anemia in patients not undergoing dialysis. N Engl J Med. 2021; 385:2313-2324. (Among 3872 patients with chronic renal disease not on dialysis treated with oral daprodustat daily or darbopoetin injections every 1 to 2 weeks for 52 weeks, changes in hemoglobin levels were similar in both groups [+0.74 vs +0.66 g/dL], and adverse event rates were similar as well for major cardiovascular and thrombotic outcomes, but cancer related deaths and tumor progression and recurrence were more frequent with daprodustat; no mention of ALT elevations or hepatotoxicity). 34739196
Singh AK, Carroll K, Perkovic V, Solomon S, Jha V, Johansen KL, Lopes RD, et al.; ASCEND-D Study Group. Daprodustat for the treatment of anemia in patients undergoing dialysis. N Engl J Med. 2021;385:2325-2335. (Among 2914 patients with anemia and chronic renal disease on dialysis treated with oral daprodustat daily or injectable erythropoietin for 52 weeks, changes in hemoglobin levels were similar in the two groups [+0.28 vs +0.10 g/dL] as well as rates of total adverse events [88% vs 85%], severe adverse events [52% vs 51%], major cardiovascular events and thrombotic events; no mention of ALT elevations or hepatotoxicity). 34739194
Coyne DW, Singh AK, Lopes RD, Bailey CK, DiMino TL, Huang C, Connaire J, et al. Three times weekly dosing of daprodustat versus conventional epoetin for treatment of anemia in hemodialysis patients: ASCEND-TD: a phase 3 randomized, double-blind, noninferiority trial. Clin J Am Soc Nephrol. 2022;17:1325-1336. (Among 407 patients with chronic renal disease and anemia treated with daprodustat orally 3 times weekly or erythropoietin 3 times weekly for 52 weeks, the two groups both had maintenance of baseline hemoglobin levels and similar adverse event rates [75% vs 79%] and “review of clinical laboratory values…revealed no notable differences between groups”). 35918106
Singh AK, Cizman B, Carroll K, McMurray JJV, Perkovic V, Jha V, Johansen KL, et al. Efficacy and safety of daprodustat for treatment of anemia of chronic kidney disease in incident dialysis patients: A randomized clinical Trial. JAMA Intern Med. 2022;182:592-602. (Among 312 patients with chronic renal disease and anemia starting or newly started on dialysis treated with daprodustat orally once daily or darbepoetin subcutaneously every 2 weeks for 52 weeks, changes in hemoglobin levels were similar in both groups [9.46 to 10.5 g/dL vs 9.49 to 10.6 g/dL] as were total adverse events [76% vs 72%] and serious adverse events [both 33%]; no mention of ALT elevations or hepatotoxicity). 35377393
Daprodustat (Jesduvroq) for anemia of chronic kidney disease. Med Lett Drugs Ther. 2024;66(1696):25-27. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of daprodustat shortly after its approval in the US for patients with anemia due to chronic renal disease who are on dialysis; no mention of ALT elevations or hepatotoxicity). 38412265

## OTHER REFERENCE LINKS

1. Recent References on Daprodustat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Daprodustat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Daprodustat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Daprodustat)